# Pulmonary Arterial Hypertension Agents

## OVERVIEW

Pulmonary artery hypertension (PAH) is marked by proliferation of vasculature and remodeling of small pulmonary arteries which causes an increase in pulmonary vascular resistance. The resultant pulmonary artery hypertension can lead to right heart failure and death. Both endothelial and smooth muscle cells appear to play a role in the development and progression of PAH. The underlying cause of most cases of PAH is unknown, but some cases are associated with autoimmune diseases such as scleroderma or systemic sclerosis. PAH is also a complication of chronic lung diseases such as chronic bronchitis and emphysema and interstitial lung diseases such as sarcoidosis. Agents used for PAH, however, are largely effective in patients with idiopathic forms of this condition who do not have major structural damage to the lungs (secondary PAH).

Pharmacotherapy of PAH has recently advanced with the development of specific antagonists and inhibitors of receptors and pathways involved in the modulation of smooth muscle tone in the pulmonary vasculature. Three major classes of agents are used: prostaglandins, endothelin receptor antagonists, and phosphodiesterase type 5 inhibitors.

Prostacyclin is a prostaglandin that is produced by endothelial cells in the lungs and directly relaxes the smooth muscle cells in the pulmonary vasculature. In idiopathic PAH, there is reduced production of prostacyclin. Stable analogues of prostacyclin have been developed which can be given by infusion or inhalation and result in temporary decrease in pulmonary artery pressure.

The endothelin receptor antagonists inhibit the binding of endothelin, a vasoconstrictive peptide, to its receptors on smooth muscle cells which results in vasodilation. Endothelin receptors are relatively enriched in pulmonary vasculature and their inhibition results in a decrease in pulmonary vascular pressure. In patients with idiopathic PAH, the endothelin receptor antagonists have been shown to improve exercise tolerance and slow progression of disease.

The phosphodiesterase type 5 (PDE5) inhibitors cause vasodilation by blocking the breakdown of intracellular cyclic guanosine monophosphate (cGMP), which results in prolongation of the action of mediators of vasodilation including nitric oxide (NO). The type-5 phosphodiesterases are isoforms of this enzyme that are found primarily in the penis and lung. For these reasons, the two major actions of the PDE5 inhibitors are to prolong penile erection and decrease pulmonary vascular pressure. They have little effects on the systemic vasculature.

Drug induced liver injury is uncommon with most agents used to treat idiopathic PAH. The exceptions are the endothelin receptor antagonists bosentan and sitaxsentan which have been implicated in several cases of clinically apparent acute liver injury. Bosentan has a boxed warning about liver injury and a requirement for monitoring liver enzymes; sitaxsentan was withdrawn from use largely because of its potential for causing severe liver injury.

The individual agents used to treat PAH are discussed individually, but references are given in the Overview sections:

- Pulmonary Arterial Hypertension Agents
  - Endothelin Receptor Antagonists
    - Ambrisentan, Bosentan, Macitentan
  - Phosphodiesterase Type 5 (PDE5) Inhibitors
    - Avanafil, Sildenafil, Tadalafil, Vardenafil
  - Prostacyclin Analogs
    - Epoprostenol, Iloprost, Treprostinil
  - Miscellaneous
    - Riociguat, Selexipag